# Chlordiazepoxide

## OVERVIEW

### Introduction

Chlordiazepoxide is an orally available benzodiazepine used for therapy of anxiety disorders and alcohol withdrawal syndromes. As with other benzodiazepines, chlordiazepoxide is not associated with serum aminotransferase or alkaline phosphatase elevations during therapy, and clinically apparent liver injury from chlordiazepoxide has been reported but is rare.

### Background

Chlordiazepoxide (klor" dye az" e pox' ide) is the prototype of benzodiazepines used in the therapy of anxiety and acute alcohol withdrawal. The antianxiety (anxiolytic) activity of the benzodiazepines is mediated by their ability to enhance gamma-aminobutyric acid (GABA) mediated inhibition of synaptic transmission through binding to the GABA A receptor. Chlordiazepoxide was approved in the United States in 1960 and for many years was one of the most prescribed medications. Currently, it no longer commonly used, having been replaced by benzodiazepines with more favorable pharmacokinetics, half-life and tolerance. Indications include anxiety disorders and alcohol withdrawal syndrome. Chlordiazepoxide is available in multiple generic forms and formerly under the brand name of Librium in capsules of 5, 10 and 25 mg. The recommended initial dose for adults is 5 to 10 mg three to four times per day, but higher doses are used for severe anxiety disorders. Chlordiazepoxide is also available for parenteral administration (100 mg/ampule) for use in acute anxiety, preoperative sedation and acute alcohol withdrawal syndromes. In addition, combinations of chlordiazepoxide with clidinium bromide or amitriptyline have been marketed under generic as well as brand names (Librax and Limbitrol). The most common side effects of chlordiazepoxide are dose related and include drowsiness, lethargy, ataxia, dysarthria and dizziness. Tolerance develops to these side effects, but tolerance may also develop to the anxiolytic effects. Chlordiazepoxide like all oral benzodiazepines has a boxed warning in its product label stressing (1) the risks of severe sedation and potentially fatal respiratory depression when combined with opiates, (2) with prolonged use, the risks of abuse, misuse, and addiction which can lead to overdose and death, and (3) with continued use, the risks of dependence and severe, potentially life-threatening withdrawal symptoms if discontinued suddenly. Benzodiazepines are all categorized as Schedule IV controlled substances, having potential for abuse, addiction, and dependence.

### Hepatotoxicity

Chlordiazepoxide, as with other benzodiazepines, is rarely associated with serum ALT elevations, and clinically apparent liver injury from its use is rare. There have been at least ten case reports of acute liver injury from chlordiazepoxide, published largely before 1980. The latency to onset of acute liver injury was 1 to 4 months, and the pattern of liver enzyme elevations varied from hepatocellular to cholestatic and mixed. The injury was usually mild-to-moderate in severity and self-limited. Fever and rash were uncommon, as was autoantibody formation.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

Chlordiazepoxide is metabolized extensively in the liver and has a prolonged half-life. The liver injury from benzodiazepines is probably due to a rarely produced metabolic intermediate metabolite.

### Outcome and Management

The case reports of hepatic injury due to benzodiazepines were marked by prompt and complete recovery upon stopping the medication, without evidence of residual or chronic injury. No cases of acute liver failure or chronic liver injury due to chlordiazepoxide have been described. There is little information about cross reactivity with other benzodiazepines, but some degree of cross sensitivity should be assumed.

Drug Class: Benzodiazepines, Antianxiety Agents

## CASE REPORT

### Case 1. Mild acute liver injury due to chlordiazepoxide.(1)

A 26 year old woman developed nausea, anorexia and fatigue 2 days after starting chlordiazepoxide (30 mg per day). She was given an injection of penicillin followed by several days of oral penicillin. Ten days later she developed jaundice and pruritus and chlordiazepoxide was stopped. She had no previous history of liver disease or known exposures to viral hepatitis. She had delivered a healthy, full-term baby shortly before starting the chlordiazepoxide. She had no known drug allergies. Physical examination showed jaundice and a tender liver, without fever or skin rash. Laboratory tests showed elevated serum bilirubin (5.0 mg/dL) and elevations in both serum alkaline phosphatase and aminotransferase levels (Table). She had severe pruritus that persisted for several weeks, even while her laboratory test results improved. A liver biopsy showed intra-hepatic cholestasis. Two months later her symptoms had resolved and all blood tests had returned to normal.

#### Key Points

Medication: | Chlordiazepoxide
Pattern: | Cholestatic (R=0.3)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2 days to symptoms, 11 days to jaundice
Recovery: | 2 months
Other medications: | Penicillin G

#### Laboratory Values

Time After Starting | Time After* Stopping | AST* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
2 weeks | 0 | 51 | 69 | 5.0 | Admission
3 weeks | 7 days | 45 | 50 | 4.4 | Liver biopsy
4 weeks | 14 days | 55 | 47 | 4.3
4.5 weeks | 18 days | 52 | 39 | 3.4
5 weeks | 3 weeks | 54 | 35 | 2.8
6 weeks | 4 weeks | 35 | 20 | 1.6
7 weeks | 5 weeks | | 21 | 1.2
8 weeks | 6 weeks | | 15 | 1.1
Normal Values | | <35 | <13 | <1.2

* Some dates and values estimated from Figure 1

#### Comment

An acute cholestatic hepatitis arose within two weeks of starting chlordiazepoxide in a patient whose only other medical exposure was to a few days or penicillin. While both benzodiazepines and the penicillins can cause cholestatic hepatitis, penicillin induced liver injury is usually accompanied by other signs of hypersensitivity such as fever and rash. Cholestatic drug induced liver injury tends to be slower to resolve that hepatocellular injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Chlordiazepoxide – Generic, Librium® (Trade name discontinued)

DRUG CLASS

Benzodiazepines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Chlordiazepoxide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Chlordiazepoxide | 58-25-3 | C16-H14-Cl-N3-O

## CITED REFERENCES

1 Lo KJ, Eastwood IR, Eidelman S. (1967). Cholestatic jaundice associated with chlordiazepoxide hydrochloride (Librium) therapy. Report of a case and review of the literature. Am J Dig Dis.

## ANNOTATED BIBLIOGRAPHY

References updated: 22 June 2023

Zimmerman HJ. Benzodiazepines. Psychotropic and anticonvulsant agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 491-3. (Expert review of benzodiazepines and liver injury published in 1999; mentions rare instances of cholestatic hepatitis have been reported due to alprazolam, chlordiazepoxide, diazepam, flurazepam, and triazolam, and hepatocellular injury with clorazepate and clotiazepam, but no reports of hepatic injury with lorazepam, oxazepam, or temazepam).
Larrey D, Ripault MP. Benzodiazepines. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 455. (Review of drug induced liver injury mentions that isolated instances of acute liver injury [usually cholestatic] have been reported with alprazolam, chlordiazepoxide, diazepam, flurazepam, and triazolam; a hepatitis-like pattern has been reported with clonazepam and clorazepate).
Mihic SJ, Mayfield J, Harris RA. Hypnotics and sedatives. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 339-53. (Textbook of pharmacology and therapeutics).
Cacioppo J, Merlis S. (1961). Chlordiazepoxide hydrochloride (Librium) and jaundice: report of a case. Am J Psychiatry. (39 year old man with schizophrenia and seizures on phenytoin developed jaundice 5 days after starting chlordiazepoxide [50 mg/day] [icterus index 49.6, Alk P 3 times ULN], resolving within 3 months of stopping).
Abbruzzese A, Swanson J. (1965). Jaundice after therapy with chlordiazepoxide hydrochloride. N Engl J Med. (51 year old man developed jaundice and pruritus 4-5 weeks after starting chlordiazepoxide [bilirubin ~4.0 mg/dL, AST 300 U/L, Alk P 2.5 times ULN], biopsy showed inflammation and cholestasis, recovery not mentioned).
Pickering D. (1966). Hepatic necrosis after chlordiazepoxide therapy. N Engl J Med. (64 year old woman developed jaundice 3 weeks after 12 day course of chlordiazepoxide [bilirubin ~32 mg/dL, ALT 225 U/L, Alk P 38 U/L], prolonged course, transient ascites, prednisone therapy).
Lo KJ, Eastwood IR, Eidelman S. (1967). Cholestatic jaundice associated with chlordiazepoxide hydrochloride (Librium) therapy. Report of a case and review of the literature. Am J Dig Dis. (26 year old woman developed nausea after 2 and jaundice after 11 days of chlordiazepoxide therapy [bilirubin 5.0 mg/dL, AST 51 U/L, Alk K 69 KA ~5 times ULN], recovery over 8 weeks, marked pruritis: Case 1).
Kratzsch KH, Buttner W, Reinhardt G. (1972). [Intrahepatic cholestasis following chlordiazepoxide--contribution to the differential diagnosis of drug jaundice]. Z Gesamte. Inn Med. (3 cases of cholestatic hepatitis during chlordiazepoxide use, after 4 weeks, 6 years and 2 days [bilirubin 6.0, 1.0 and 6.4 mg/dL, ALT 245, 18 and 25 U/L, Alk P 1.6 1.0 and 20 times ULN], with rapid recovery in 1-2 months, all 3 had biopsies showing intrahepatic cholestasis).
Franks E, Jacobs WH. (1975). Cholestatic jaundice possibly due to benzodiazepine-type drugs. Mo Med. (40 year old woman on multiple drugs including chlorpromazine developed jaundice [bilirubin 2.0 rising to 9.7 mg/dL, ALT 280 U/L, Alk P 546 U/L, 16% eosinophils], seemed to worsen on benzodiazepines including chlordiazepoxide, diazepam and flurazepam, resolving rapidly when they were stopped, but attribution to benzodiazepines difficult).
Døssing M, Andreasen PB. (1982). Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol. (Among 572 cases of hepatotoxicity reported to a Danish registry between 1968 and 1978, 97 were due to psychotropic agents, but only two attributed to benzodiazepines).
Davion T, Capron-Chivrac D, Andrejak M, Capron JP. (1985). Gastroenterol Clin Biol. (Review of hepatotoxicity of anticonvulsants; among benzodiazepines, cases of cholestatic hepatitis have been linked to chlordiazepoxide and diazepam, but liver injury from this class of drugs is exceptionally rare).
Wallace SJ. (1996). A comparative review of the adverse effects of anticonvulsants in children with epilepsy. Drug Saf. (Systematic review; ALT elevations occur in 4% of children on phenytoin, 6% on valproate, 1% on carbamazepine; “No child taking… benzodiazepines had raised liver enzyme levels,”).
Lewis JH, Zimmerman HJ. (1999). Drug- and chemical-induced cholestasis. Clin Liver Dis. (Review of drug induced cholestatic syndromes, listing many causes including chlordiazepoxide and flurazepam; “Benzodiazepines may cause cholestatic injury, although this is rare”).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 20 were attributed to benzodiazepines including 5 for clorazepate, 5 alprazolam, 6 lorazepam and 4 diazepam, but none attributed to chlordiazepoxide).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to a benzodiazepine).
Björnsson E. (2008). Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scand. (Review of hepatotoxicity of all anticonvulsants focusing upon phenytoin, valproate, carbamazepine; “Furthermore, hepatoxicity has not been convincingly shown to be associated with the use of benzodiazepines”).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were linked benzodiazepines).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to chlordiazepoxide or other benzodiazepines).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature on drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to a chlordiazepoxide or other benzodiazepine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to chlordiazepoxide or any other benzodiazepine).
(2019). Drugs for anxiety disorders. Med Lett Drugs Ther. (Concise review of drugs for anxiety including SSRIs, SNRIs and benzodiazepines including mechanism of action, clinical efficacy, safety, and costs; does not mention ALT elevations or hepatotoxicity).
(2023). Drugs for chronic insomnia. Med Lett Drugs Ther. (Concise review of drugs for chronic insomnia mentions that tolerance and dependence can occur with use of benzodiazepines and their use should be discouraged, and that benzodiazepines are CNS suppressants and can impair next day performance including driving and cause complex behavior disorders, retrograde amnesia, dependence, tolerance, abuse and rebound insomnia; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Chlordiazepoxide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Chlordiazepoxide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Chlordiazepoxide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Chlordiazepoxide)